# Atazanavir

## OVERVIEW

### Introduction

Atazanavir is an antiretroviral protease inhibitor that is used in the therapy and prevention of human immunodeficiency virus (HIV-1) infection and the acquired immunodeficiency syndrome (AIDS). Atazanavir can cause transient and usually asymptomatic elevations in serum aminotransferase levels, mild elevations in indirect bilirubin concentration and, rarely, clinically apparent, acute liver injury. In HBV or HCV coinfected patients, highly active antiretroviral therapy with atazanavir may result of an exacerbation of the underlying chronic hepatitis B or C.

### Background

Atazanavir (a" ta zan' a vir) is proteinomimetic, azapeptide that binds to the active, catalytic site of the HIV-1 protease preventing cleavage and processing of viral polyprotein precursors into mature, functional proteins that are necessary for viral replication. Atazanavir, in combination with other antiretroviral agents, has been shown to be effective in lowering HIV RNA levels and improving CD4+ lymphocyte counts in patients with HIV infection and AIDS. Atazanavir was approved for use in the United States in 2003 for the treatment of HIV infection and is typically given in combination with low “booster” doses of ritonavir or with the pharmacologic enhancer cobicistat, which improve its pharmacokinetics by inhibiting its metabolism by CYP 3A4. Atazanavir is available under the brand name Reyataz in capsules of 150, 200 and 300 mg. The recommended adult dosage is 400 mg once daily or 300 mg if given with ritonavir (100 mg) once daily. A fixed combination of atazanavir with the cobicistat (300 mg/150 mg) is also available under the brand name Evotaz. The recommended dose of the combination formulation is one tablet daily. The most common side effects of atazanavir are nausea, diarrhea, gastrointestinal upset, headache, fatigue, rash, hypersensitivity reactions, hyperbilirubinemia and, with long term use, hyperlipidemia and lipodystrophy.

### Hepatotoxicity

Atazanavir can cause several forms of liver injury including transient serum enzyme elevations, indirect hyperbilirubinemia, idiosyncratic acute liver injury and exacerbation of underlying chronic viral hepatitis.

Some degree of serum aminotransferase elevations occurs in a high proportion of patients taking atazanavir containing antiretroviral regimens. Moderate-to severe elevations in serum aminotransferase levels (>5 times the upper limit of normal) are found in 3% to 10% of patients, although rates may be higher in patients with HIV-HCV coinfection. These elevations are usually asymptomatic and self-limited and can resolve even with continuation of the medication.

Atazanavir therapy (similar to indinavir) also causes increases in unconjugated (indirect) and total serum bilirubin that can manifest as jaundice in up to 10% of patients. These elevations are due to the inhibition of UDP glucuronyl transferase, the hepatic enzyme responsible for conjugation of bilirubin that is deficient in Gilbert syndrome. The hyperbilirubinemia is usually mild, the increases averaging 0.3-0.5 mg/dL, but can be more marked in patients with Gilbert syndrome with increases of 1.5 mg/dL or more and clinical jaundice. The jaundice, however, is not indicative of hepatic injury.

Clinically apparent acute liver injury due to atazanavir is rare and the clinical pattern of liver injury, latency and recovery have not been well defined. The liver injury is idiosyncratic and rare and probably similar to the injury that is caused by other HIV protease inhibitors. The liver injury typically arises 1 to 8 weeks after starting the protease inhibitor and has variable patterns of liver enzyme elevation, from hepatocellular to cholestatic. Signs of hypersensitivity (fever, rash, eosinophilia) are rare, as is autoantibody formation. The acute liver injury is usually self-limited and resolves within a few weeks of stopping the antiretroviral agent (Case 1).

In addition, initiation of atazanavir based antiretroviral therapy can lead to exacerbation of an underlying chronic hepatitis B or C in coinfected individuals, typically arising 2 to 12 months after starting therapy, and associated with a hepatocellular pattern of serum enzyme elevations and increases in serum levels of hepatitis B virus (HBV) DNA or hepatitis C virus (HCV) RNA. Atazanavir therapy has not been clearly linked to lactic acidosis and acute fatty liver that is reported in association with several nucleoside analogue reverse transcriptase inhibitors.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the clinical hepatotoxicity from atazanavir is only partially known. The indirect hyperbilirubinemia associated with its use is caused by inhibition of hepatic conjugation of bilirubin, similar to what occurs in Gilbert syndrome and is not indicative of liver injury. Atazanavir is extensively metabolized by the liver, largely by the cytochrome P450 system (CYP 3A4) and toxic intermediates may be the cause of the idiosyncratic forms of liver injury. In patients with HIV infection who are coinfected with either HBV or HCV, initiation of potent antiretroviral therapy may be associated with flares of the underlying chronic hepatitis as the result of reconstitution of the immune system, viral interactions or a direct effect of the drug on the hepatitis virus.

### Outcome and Management

The severity of liver injury from atazanavir ranges from asymptomatic unconjugated hyperbilirubinemia to moderate serum aminotransferase elevations to acute hepatitis. In typical cases, recovery occurs within 1 to 2 months and neither chronic hepatitis nor vanishing bile duct syndrome have been reported due to atazanavir. Rechallenge may lead to recurrence and should be avoided. There does not appear to be cross sensitivity in the hepatic injury to other protease inhibitors or antiretroviral agents. The exacerbation of hepatitis B or C that can occur with atazanavir based antiretroviral therapies can be severe and lead to liver failure or progressive, end stage liver disease. Patients with HCV or HBV coinfection should be monitored prospectively for viral and serum aminotransferase levels and appropriate therapy instituted if possible.

References to atazanavir are included with references to all the HIV protease inhibitors in the overview section of Protease Inhibitors (updated September 2017). Most of the HIV protease inhibitors in clinical use are proteinomimetic drugs and are structurally unrelated.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Protease Inhibitors: Amprenavir, Darunavir, Fosamprenavir, Indinavir, Lopinavir, Nelfinavir, Ritonavir, Saquinavir, Tipranavir

## CASE REPORT

### Case 1. Serum aminotransferase elevations and jaundice arising during atazanavir therapy.

[Modified from: Eholié SP, Lacombe K, Serfaty L, Wendum D, Girard PM. Acute hepatic cytolysis in an HIV-infected patient taking atazanavir. AIDS 2004; 18: 1610-1. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/15238786)]

A 56 year old woman with HIV infection and long history of antiretroviral therapy developed elevations in serum aminotransferase levels 8 weeks after switching from lopinavir/ritonavir to atazanavir in combination with tenofovir and didanosine. In the previous five years, she had been treated with various antiretroviral regimens which had included stavudine, didanosine, efavirenz, abacavir, nelfinavir, lopinavir and ritonavir, and had complications of lipodystrophy and dyslipidemia. Tests for hepatitis A, B and C were negative as were autoantibodies. She did not drink alcohol and was taking no other medications. Because of improvements in her dyslipidemia after switching to atazanavir, the medication was continued and she was monitored. Thirty weeks after starting atazanavir, serum ALT levels had risen to more than ten-fold elevated and she was jaundiced (Table). Ultrasonography showed fatty liver without evidence of obstruction and liver biopsy showed steatosis and an acute hepatitis-like picture. Antiretroviral treatment was discontinued and serum aminotransferase levels fell to near normal levels within the next 2 months. She tolerated reintroduction of antiretroviral therapy with tenofovir, didanosine and nelfinavir without recurrence of ALT elevations.

#### Key Points

Medication: | Atazanavir
Pattern: | Hepatocellular (R=8.3)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 8 weeks to onset of ALT elevations, 30 weeks to jaundice
Recovery: | Yes
Other medications: | Tenofovir, didanosine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 27 | Normal | Normal
Pre | | 25
Atazanavir started and lopinavir stopped because of dyslipidemia
7 weeks | | 105
4 months | | 90
7 months | | 265
7.5 months | 0 | 405 | 158 | 4.6 | Therapy stopped
8 months | 1 week | 290
9 months | 6 weeks | 240
| 8 weeks | 110 | | | Tenofovir restarted
10 months | 3 months | 48
11 months | 4 months | 30
Normal Values | | <40 | <130 | <1.2

*Values estimated from Figure 1.

#### Comment

Mild, asymptomatic elevations in serum aminotransferase levels were identified within 8 weeks of switching HIV protease inhibitors from lopinavir/retonavir to atazanavir. However, instead of resolving spontaneously, ALT levels continued to increase. It was not clear whether the patient became symptomatic or whether the jaundice may have been partially due to the known effects of atazanavir in increasing unconjugated (indirect) bilirubin levels. The appearance of ALT elevations shortly after starting atazanavir, the absence of other known causes of liver diseases (particularly hepatitis B and C) and the resolution with stopping support the diagnosis of atazanavir induced liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Atazanavir – Reyataz®, Evotaz® (with Cobicistat)

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=atazanavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Atazanavir | 198904-31-3 | C38-H52-N6-O7 | Atazanavir Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Atazanavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Atazanavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Atazanavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Atazanavir)